# Docetaxel

## OVERVIEW

### Introduction

Docetaxel is an antineoplastic agent that has a unique mechanism of action as an inhibitor of cellular mitosis and that currently plays a central role in the therapy of many solid tumors including breast and lung cancer. Docetaxel therapy is frequently associated with serum enzyme elevations which are usually transient and mild, but more importantly has been linked to rapid onset, severe hypersensitivity reactions that can be associated with acute hepatic necrosis, liver failure and death.

### Background

Docetaxel (doe" se tax' el) is a complex diterpenoid molecule that contains a central 8-member taxane ring. Docetaxel is a semisynthetic analogue of paclitaxel and was initially isolated from the needles of the European Yew tree (Taxus baccata). It is a potent antineoplastic agent and its mechanism of action appears to be mediated by its binding to microtubulin, which is important in the mitotic phase of cell division. The binding of docetaxel prevents the disassembly of the cytoskeletal microtubules, preventing cell division and leading to cell death. Docetaxel was approved for use in the United States in 1996 and it remains an important agent in the therapy of several neoplasms including breast, gastric, prostate, head and neck, and non-small cell lung cancer. Docetaxel is available in solution for injection generically and under the brand names such as Taxotere and Docefrez. Docetaxel is administered intravenously, typically as one hour infusions every three weeks in combination with other antineoplastic agents. The dose varies by indication and body weight. Preexisting liver disease is considered a relative contraindication of its use. Side effects are common and include diarrhea, nausea, vomiting, mucositis, fatigue, myalgias, skin rash, alopecia, phlebitis, bone marrow suppression, fluid retention, cardiomyopathy, peripheral neuropathy and hypersensitivity reactions. Premedication with oral corticosteroids is recommended to prevent or at least ameliorate severe hypersensitivity reactions. The product label for docetaxel includes a black box warning of toxic deaths, hepatotoxicity, neutropenia, hypersensitivity reactions and fluid retention, with rates of death ranging from 0.6% to 2.8% of patients, the highest risk in those with preexisting liver test abnormalities.

### Hepatotoxicity

Docetaxel has been associated with serum aminotransferase elevations in up to half of patients, but values greater than 5 times the upper limit of normal (ULN) occur in less than 2%. Similar rates of alkaline phosphatase elevations and occasional mild bilirubin elevations also occur. The abnormalities are usually asymptomatic, mild and self-limited, rarely requiring dose modification or discontinuation. Despite the frequency of serum enzyme elevations during therapy, clinically apparent liver injury from docetaxel is rare. Nevertheless, individual case reports of severe acute hepatic necrosis attributed to docetaxel have been published, usually arising within a few days or weeks after a severe hypersensitivity reaction to the first or second infusion of docetaxel (Case 1). The typical case arises within days of the infusion of docetaxel and is associated with rapid, marked rises in serum aminotransferase levels with subsequent appearance of jaundice. With severe injury there is early hepatic and multiorgan failure with jaundice and progressive hepatic encephalopathy, coagulopathy, and ascites. Immunoallergic features (fever, rash, flushing) are common initially, but may be obscured by corticosteroid therapy. Liver biopsy generally reveals zone 3 (centrolobular) necrosis and variable degrees of inflammation and cholestasis. Because docetaxel is often given with other antineoplastic agents, liver injury arising during therapy cannot always be attributed reliably to docetaxel as opposed to another specific agent. Furthermore, docetaxel in combination with other antineoplastic agents may be associated with reactivation of hepatitis B, increased risk of opportunistic viral infections, sinusoidal obstruction syndrome and sepsis, any of which can cause liver test abnormalities or clinically apparent liver injury.

Likelihood score: C (probable cause of acute hepatic necrosis associated with a hypersensitivity reaction to an infusion).

### Mechanism of Injury

Docetaxel likely has a direct toxic effect on hepatocytes, accounting for the frequency of serum enzyme elevations during therapy, particularly with higher doses. Cases of clinically apparent liver injury have usually occurred in the setting of a severe hypersensitivity reaction, implying an immunoallergic component of injury. Docetaxel is metabolized in the liver by the cytochrome P450 system, predominantly CYP 3A4 and 3A5 and metabolites excreted in bile and feces.

### Outcome and Management

Clinically significant liver injury from docetaxel is uncommon. Nevertheless, routine monitoring of liver tests is recommended before each docetaxel infusion, and administration held if serum bilirubin is elevated, ALT or AST are above 1.5 times ULN or alkaline phosphatase is above 2.5 times ULN. The serum enzyme elevations that occur on docetaxel therapy are usually self-limited and resolve with temporary discontinuation or modification of dosage. Liver injury associated with hypersensitivity reactions can be severe and docetaxel should be discontinued immediately. Re-exposure should be avoided. Because docetaxel is a structural analogue of paclitaxel, some degree of cross sensitivity to hypersensitivity reactions and hepatic injury should be expected. High doses of corticosteroids are often used to treat the hypersensitivity reaction, but it is not clear whether corticosteroids ameliorate the liver damage.

Drug Class: Antineoplastic Agents, Taxanes

Other Drugs in the Subclass, Taxanes: Cabazitaxel, Paclitaxel

## CASE REPORT

### Case 1. Acute hepatocellular injury after an infusion of docetaxel.(1)

A 31 year old woman with endometrial cancer developed abdominal pain and serum aminotransferase elevations the week following an initial infusion of docetaxel and carboplatin. She had no history of liver disease, drug allergies, alcohol abuse or risk factors for viral hepatitis. Her other medical conditions included seasonal allergies, reactive airway disease and dyspepsia. Her endometrial carcinoma was initially treated surgically with hysterectomy and bilateral oophorectomy, followed by pelvic irradiation and intravenous cisplatin which was poorly tolerated. She then started paclitaxel and carboplatin but had an immediate hypersensitivity reaction during the infusion manifested by chest tightness with arm and facial flushing despite premedication with antihistamines and dexamethasone. The following week her chemotherapy regimen was switched to docetaxel and carboplatin with intravenous dexamethasone followed by oral dexamethasone. She had mild symptoms of hypersensitivity during the infusions, but during the ensuing week she developed fatigue and abdominal pain. At the time of the next planned infusion, serum ALT was found to be 649 U/L, AST 211 U/L and alkaline phosphatase 161 U/L (R=11.7: hepatocellular). Serum bilirubin and albumin were normal and INR 0.9. (Table). Therapy was held. The following day, serum ALT levels had decreased. Serologic markers for acute hepatitis A, B and C were negative. Serum ANA was weakly positive (1:80) but SMA and AMA were negative. Imaging of the liver was normal without evidence of biliary or portal venous obstruction. Her symptoms resolved and over the next few weeks her serum aminotransferase levels fell to near normal levels. She was restarted on carboplatin without docetaxel and serum enzymes remained normal or minimally elevated.

#### Key Points

Medication: | Docetaxel (124 mg iv once)
Pattern: | Hepatocellular (R=11.7)
Severity: | 1+ symptomatic (no jaundice)
Latency: | 1 week
Recovery: | 5 weeks
Other medications: | Carboplatin, dexamethasone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre (-2 mo) | Pre | 25 | 73 | 0.2
Pre (-1 mo) | Pre | Paclitaxel and carboplatin: hypersensitivity reaction during infusion
Pre (-1 wk) | Pre | 35 | 66 | 0.3 | Docetaxel and carboplatin
7 days | 0 | 649 | 161 | 0.2 | Therapy held
8 days | 1 day | 545 | 148 | 0.3 | INR 0.9
14 days | 7 days | 295 | 92 | 0.3
19 days | 12 days | 126 | 78 | 0.2 | Carboplatin restarted
26 days | 19 days | 64 | 87 | 0.3
35 days | 28 days | 94 | 95 | 0.3
44 days | 37 days | 30 | 84 | 0.2
Normal Values | | <40 | <125 | <1.2

#### Comment

This young woman with endometrial cancer and history of season allergies, had a mild hypersensitivity reaction during an infusion of paclitaxel and significant hepatic injury with a subsequent single infusion of docetaxel. The injury was symptomatic but without jaundice or evidence of hepatic synthetic dysfunction. The rapid rise and equally rapid fall in serum aminotransferase levels suggests direct hepatic injury and acute hepatic necrosis. In this case the injury was mild and self-limited injury, but docetaxel hypersensitivity reactions can be severe and associated with jaundice and hepatic failure. This patient appeared to have cross sensitivity with paclitaxel.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Docetaxel – Generic, Taxotere®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Docetaxel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Docetaxel | 148408-66-6 | C43-H53-N-O14.3H2-O

## CITED REFERENCE

1 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2020

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp.673-708. (Textbook of hepatotoxicity published in 1999; docetaxel is not mentioned).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; the taxanes are not specifically discussed).
Wellstein A, Giaccone G, Atkins MB, Sausille EA. Taxanes. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1187-9. (Textbook of pharmacology and therapeutics).
Blaney SM, Seibel NL, O'Brien M, Reaman GH, Berg SL, Adamson PC, Poplack DG, et al. (1997). Phase I trial of docetaxel administered as a 1-hour infusion in children with refractory solid tumors: a collaborative pediatric branch, National Cancer Institute and Children's Cancer Group trial. J Clin Oncol. (44 children with refractory solid tumors were given 103 courses of docetaxel every 21 days; major dose limiting toxicities were neutropenia, mild ALT elevations [<3 times ULN] occurred, but frequency and details were not given).
Von Hoff DD. (1997). The taxoids: same roots, different drugs. Semin Oncol. (Review of the development of paclitaxel and docetaxel, clinical use, efficacy and toxicity stressing the differences between the two taxoids, which are due largely to differences in pharmacokinetics).
Picus J, Schultz M. (1999). Docetaxel (Taxotere) as monotherapy in the treatment of hormone-refractory prostate cancer: preliminary results. Semin Oncol. (35 patients with prostate cancer were treated with docetaxel every 3 weeks [average of 6 cycles]; one had marked ALT elevations, but also had liver metastases).
Crown J. (1999). A review of the efficacy and safety of docetaxel as monotherapy in metastatic breast cancer. Semin Oncol. (Brief review of safety and efficacy of docetaxel in advanced breast cancer; no discussion of hepatotoxicity or ALT elevations).
Burris HA. (1999). Single-agent docetaxel(Taxotere) in randomized phase III trials. Semin Oncol. (Review of 3 randomized trials of docetaxel vs standard chemotherapy in women with breast cancer; adverse events were common, but hepatotoxicity was not mentioned).
Fumoleau P. (1997). Efficacy and safety of docetaxel in clinical trials. Am J Health Syst Pharm. (Overall response rates to docetaxel and paclitaxel in advanced breast cancer ranged from 29-68% of patients; major dose related toxicities included neutropenia, mucositis, cardiomyopathy and fluid retention; hepatotoxicity was not mentioned).
Alexandre J, Bleuzen P, Bonneterre J, Sutherland W, Misset JL, Guastalla J, Viens P, et al. (2000). Factors predicting for efficacy and safety of docetaxel in a compassionate-use cohort of 825 heavily pretreated advanced breast cancer patients. J Clin Oncol. (Among 825 patients with breast cancer undergoing therapy with docetaxel, the risk for febrile neutropenia was increased in those with liver dysfunction as defined by ALT or AST >1.5 and Alk P >3 times ULN [odds ratio 1.86]).
Tomassini E, Muhizi J, al Raheb K, Steinbach G, Bemer M, Platini C. (2001). Presse Med. (52 year old woman with metastatic breast cancer developed jaundice and stupor 72 hours after an initial infusion of docetaxel [bilirubin 6.8 mg/dL, ALT 5540 U/L, GGT 116 U/L, protime 18 sec], with death from multiorgan failure and autopsy showing massive necrosis).
Venturini M, Del Mastro L, Garrone O, Angiolini C, Merlano M, Bergaglio M, Tolino G, et al. (2002). Phase I, dose-finding study of capecitabine in combination with docetaxel and epirubicin as first-line chemotherapy for advanced breast cancer. Ann Oncol. (Among 23 women with advanced breast cancer treated with 139 cycles of docetaxel, capecitabine and epirubicin, 2 were withdrawn because of hepatic toxicity).
Yeo W, Mok TS, Tse KK, Kwan WH, Lam KC, Ho WM, Chiu SK, et al. (2002). Phase II study of docetaxel and epirubicin in Chinese patients with metastatic breast cancer. Anticancer Drugs. (Among 46 patients treated with docetaxel and epirubicin, 6 [13%] developed abnormal ALT levels including two with hepatitis B reactivation, the 4 without hepatitis B being mild and transient).
Sundar S, Chan SY. (2003). Cholestatic jaundice and pseudomembranous colitis following combination therapy with doxorubicin and docetaxel. Anticancer Drugs. (45 year old woman with advanced breast cancer developed febrile neutropenia after 2 cycles of docetaxel and doxorubicin with subsequent pseudo-membranous colitis and jaundice [peak bilirubin 5.3 mg/dL, ALT 46 U/L, Alk P 3436 U/L], resolving within 2 months).
Pelegrí A, Calvo L, Mayordomo J I, Florián J, Vázquez S, Arcusa A, Martn-Richard M, et al., Spanish Group for Breast Cancer Research (GEICAM). (2004). Gemcitabine plus docetaxel administered every other week as first-line treatment of metastatic breast cancer: preliminary results from a phase II trial. Semin Oncol. (Among 35 patients with metastatic breast cancer treated with up to 10 cycles of docetaxel and gemcitabine, 51% had aminotransferase elevations, which were >5 times ULN in 6%, but largely asymptomatic and self-limited).
Goodin S, Medina P, Capanna T, Shih WJ, Abraham S, Winnie J, Doyle-Lindrud S, et al. (2005). Effect of docetaxel in patients with hormone-dependent prostate-specific antigen progression after local therapy for prostate cancer. J Clin Oncol. (Among 25 patients with advanced prostate cancer given docetaxel in 3 week cycles, one had dose reduction for ALT elevations >5 times ULN).
Kaira K, Takise A, Minato K, Iwasaki Y, Ishihara S, Takei Y, Tsuchiya S, et al. (2005). Phase II study of weekly docetaxel and cisplatin in patients with non-small cell lung cancer. Anticancer Drugs. (Among 40 patients with lung cancer treated with weekly docetaxel and cisplatin, 2 had ALT elevations >5 times ULN leading to dose reduction in 1).
Cao Y, Wang ZQ, Guo Y, Feng FY, Hu XH, Xiong JP, Tang GD, et al. (2006). Ai Zheng.
Kasahara K, Kimura H, Shibata K, Araya T, Sone T, Oribe Y, Furusho S, et al. (2006). A phase II study of combination chemotherapy with docetaxel and carboplatin for patients with advanced or metastatic non-small cell lung cancer. Anticancer Res. (Among 40 patients with advanced lung cancer treated with docetaxel and carboplatin, 6 [15%] had ALT elevations which were above 5 times ULN in one).
Liu DG, Peng RJ, Feng FY, Hu XH, Tang GD, Xiong JP, Zhao HY, et al. (2006). Ai Zheng. (Comparison of two formulations of docetaxel in 67 patients with advanced breast cancer found that transient ALT and AST elevations were common).
Sinibaldi VJ, Elza-Brown K, Schmidt J, Eisenberger MA, Rosenbaum E, Denmeade SR, Pili R, et al. (2006). Phase II evaluation of docetaxel plus exisulind in patients with androgen independent prostate carcinoma. Am J Clin Oncol. (Among 14 patients with prostate cancer treated with docetaxel and exisulind, 21% had aminotransferase elevations above 5 times ULN).
Aoki H, Ishidoya S, Ito A, Endoh M, Shimazui T, Arai Y. (2006). Experience of the treatment with gemcitabine, docetaxel, and carboplatin(GDC) chemotherapy for patients with small-cell carcinoma of the prostate. Int J Urol. (Two patients with advanced prostate cancer were treated with docetaxel in combination with gemcitabine and carboplatin; one developed acute liver failure several months after a fifth cycle which was attributed to herpes zoster).
Ohlmann CH, Kohlmorgen S, Sahi D, Engelmann U, Heidenreich A. (2007). Urologe A. (67 year old man with prostate cancer developed Stevens-Johnson Syndrome, neutropenia and thrombocytopenia after 5 weekly infusions of docetaxel, with subsequent rise in liver tests and jaundice that progressed to hepatic failure and death; few details provided).
Chen JP, Lo Y, Yu CJ, Hsu C, Shih JY, Yang CH. (2008). Predictors of toxicity of weekly docetaxel in chemotherapy-treated non-small cell lung cancers. Lung Cancer. (Retrospective analysis of toxicity of 455 cycles of docetaxel in 155 patients with non-small cell lung cancer; 67 patients were withdrawn for toxicity, 2 were liver related; preexisting hepatitis B and C were risk factors for toxicity).
James J, Murry DJ, Treston AM, Storniolo AM, Sledge GW, Sidor C, Miller KD. (2007). Phase I safety, pharmacokinetic and pharmacodynamic studies of 2-methoxyestradiol alone or in combination with docetaxel in patients with locally recurrent or metastatic breast cancer. Invest New Drugs. (Among 15 women with advanced breast cancer treated with docetaxel and 2-methoxyestradiol, 3 [20%] had ALT elevations, which resolved with dose reductions in 2 and stopping docetaxel in 1).
Minami H, Kawada K, Sasaki Y, Tahara M, Igarashi T, Itoh K, Fujii H, et al. (2009). Population pharmacokinetics of docetaxel in patients with hepatic dysfunction treated in an oncology practice. Cancer Sci. (Analysis of pharmacokinetics of docetaxel in 200 patients found that liver test abnormalities were associated with delayed clearance and recommended 20-40% reduction in dose).
Kobayashi K, Yokonishi T, Ito Y, Matsumoto T, Umemoto S, Osaka K, Nakamura M, et al. (2010). Hinyokika Kiyo. (Among 62 patients with advanced prostate cancer treated with docetaxel, estramustine and dexamethasone for an average of 11 cycles, only 1 had transient ALT elevation >5 times ULN).
Wang Z, Liang X, Yu J, Zheng X, Zhu Y, Yan Y, Dong N, et al. (2012). Non-genetic risk factors and predicting efficacy for docetaxel--drug-induced liver injury among metastatic breast cancer patients. J Gastroenterol Hepatol. (Among 647 women with breast cancer treated with docetaxel, 67 [10%] developed liver injury [27% with jaundice], with a median time to onset of 14 days; risk factors were menopausal status, hepatitis B markers, and presence of liver metastases).
Liang X, Zhang J, Zhu Y, Lu Y, Zhou X, Wang Z, Yu J, et al. (2013). Specific genetic polymorphisms of IL10-592 AA and IL10-819 TT genotypes lead to the key role for inducing docetaxel-induced liver injury in breast cancer patients. Clin Transl Oncol. (Among 129 patients with metastatic breast cancer treated with docetaxel, there were significant associations between specific polymorphisms of IL10, but not tumor necrosis factor and 40 instances of acute liver injury; although the associations were slight).
Mandaliya H, Baghi P, Prawira A, George MK. (2015). A rare case of paclitaxel and/or trastuzumab induced acute hepatic necrosis. Case Rep Oncol Med. (62 year old woman with metastatic breast cancer received 4 cycles of doxorubicin and cyclophosphamide and developed pulmonary edema and respiratory failure within 12 hours of an initial infusion of paclitaxel and trastuzumab, dying one day later and autopsy showing acute hepatic necrosis; no liver test results provided).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents of which only 1 was due to a taxane [docetaxel] Case 1).
Oudard S, Fizazi K, Sengeløv L, Daugaard G, Saad F, Hansen S, Hjälm-Eriksson M, et al. (2017). Cabazitaxel versus docetaxel as first-line therapy for patients with metastatic castration-resistant prostate cancer: a randomized phase III trial-FIRSTANA. J Clin Oncol. (Among 1,168 patients with metastatic prostate cancer treated with cabazitaxel or docetaxel, overall survival rates were similar while adverse events were higher in a higher dose arm of cabazitaxel; ALT elevations and hepatotoxicity were not mentioned).

## OTHER REFERENCE LINKS

1 Recent References on Docetaxel: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Docetaxel/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Docetaxel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Docetaxel)